# Halogenated Anesthetics

## OVERVIEW

The halogenated inhalational anesthetics have been linked to idiosyncratic liver injury for more than 50 years. These agents induce anesthesia by blocking CNS neurotransmission, although the exact mechanism of action is unknown. They are currently the most commonly used inhalational anesthetics in surgery. In the United States, the five halogenated anesthetics in current use are halothane, isoflurane, enflurane, desflurane, and sevoflurane. Halothane is now rarely used outside of pediatrics because of its potential to cause idiosyncratic severe liver injury, which is rare in children.

The classic form of anesthetic induced liver injury was associated with halothane, which was introduced into practice in 1956 and rapidly became the most commonly used agent for general anesthesia. Within a few years of its introduction, however, case reports of liver injury possibly due to halothane began to appear. There was initially great resistance to acceptance of the hepatotoxicity of halothane, largely because of its excellent safety record in other respects and the rarity of the hepatic reaction. Eventually, however, the potential hepatotoxicity of halothane became quite clear. By the 1970s, halothane had become the most common cause of idiosyncratic, drug induced acute liver failure and more than 1000 cases of clinically apparent liver injury had been described in the literature. Furthermore, a reasonable mechanism of hepatic injury by halothane was delineated based upon its extensive metabolism (oxidation) by the major drug metabolizing enzyme system of the liver, specifically the cytochrome P450, CYP 2E1. The metabolism of halothane to a trifluoroacetylated reactive intermediate with subsequent binding to intrahepatic cytosolic proteins was believed to create an antigenic molecule capable of inducing allergic and cytotoxic reactions. This proposed mechanism also matched the allergic, clinical features of halothane hepatitis, marked by a typical incubation period of 7 days after anesthesia, accompanied often by fever, rash, arthralgias and eosinophilia and recurring with reexposure in an accelerated and often more severe form. Thus, the overall rate of occurrence of significant liver injury after halothane was estimated at 1 per 15,000 initial exposures, and probably 1 per 1000 repeated exposures, particularly if the reexposure was within 28 days. Having become the most common drug induced cause of acute liver failure in the United States and most of the world, halothane subsequently became less commonly used and is rarely employed currently.

Other halogenated anesthetics have been introduced and become the major agents currently in use in the United States, including enflurane (1972), isoflurane (1981), desflurane (1993) and sevoflurane (1995). These agents have the theoretical advantage of less metabolism by the CYP 2E1 system (20% by halothane compared to 3% by sevoflurane, 2.4% by enflurane, 0.2% by isoflurane, and 0.01% by desflurane). Nevertheless, rare instances of acute liver injury have been reported with all agents. Furthermore, the pattern of injury described with the newer halogenated anesthetics has resembled that of halothane hepatitis, and trifluoroacetyl adducts have been identified in liver tissue and antibodies to be the adducts in serum of patients with hepatic injury from these other agents. Nevertheless, anesthetic induced acute liver failure is now rare and no longer ranked among the more common causes of drug induced liver disease or acute liver failure.

The various structures of the halogenated anesthetics are shown below. Each agent is discussed separately with individual clinical cases and references.

The following links are to individual drug records.

- Desflurane
- Enflurane
- Halothane
- Isoflurane
- Sevoflurane

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Desflurane | 57041-67-5 | C3-H2-F6-O | Desflurane chemical structure
Enflurane | 13838-16-9 | C3-H2-Cl-F5-O | Enflurane chemical structure
Halothane | 151-67-7 | C2-H-Br-Cl-F3 | Halothane chemical structure
Isoflurane | 26675-46-7 | C3-H2-Cl-F5-O | Isoflurane chemical structure
Sevoflurane | 28523-86-6 | C4-H3-F7-O | Sevoflurane chemical structure